# Nitisinone

## OVERVIEW

### Introduction

Nitisinone is an inhibitor of the tyrosine catabolism that is used to treat hereditary tyrosinemia, type 1, in which accumulation of intermediates of tyrosine metabolism causes severe and progressive hepatic and renal injury. Nitisinone has been associated with mild, transient serum aminotransferase elevations, but has not been linked to instances of clinically apparent acute liver injury or jaundice.

### Background

Nitisinone (nye tis’ i none) is a small molecule inhibitor of 4-hydroxyphenylpyruvate the second enzymatic step in tyrosine metabolism (see Figure 1). Developed initially as an herbicide, it was later found to be beneficial in hereditary type 1 tyrosinemia in which the absence of fumarylacetoacetate hydrolase (FAH), the fifth step in tyrosine catabolism, causes buildup of toxic intermediates that cause early onset liver failure and severe renal tubular dysfunction. Treatment of infants and children with nitisinone combined with a low protein diet led to reversal of liver failure and correction of renal tubular dysfunction, allowing for normal growth and development. Children treated before the onset of liver failure avoided the need for liver transplantation and did not develop hepatocellular carcinoma, common outcomes before the availability of this agent. Nitisinone was approved as an orphan drug for use in tyrosinemia, type 1, in the United States in 2002. Nitisinone is available in tablets of 2, 5, 10 and 20 mg and as an oral suspension of 4 mg/mL under the brand name Orfadin. The recommended dose is 0.5 mg/kg orally given twice daily, but monitoring with drug and tyrosine levels is usually recommended and can lead to dose modification. Side effects are infrequent, but serious complications include corneal irritation, opacities and ulcers, skin rash, developmental delay and intellectual disability, leukopenia and thrombocytopenia. Most of these serious side effects of nitisinone are thought to be due to the elevation in plasma tyrosine levels which typically increase ten-fold during treatment. These increases can be partially prevented by limiting tyrosine and phenylalanine intake by a low or limited protein diet, a necessary component in the therapy of this disease.

Figure 1. Metabolic Disorders of Tyrosine and Nitisinone Action.

Nitisinone fig 1

### Hepatotoxicity

Type 1 tyrosinemia is a rare disease and clinical experience with use of nitisinone is limited. Therapy can be accompanied by mild elevations in serum aminotransferase levels, but these are generally mild (less than 3 times the upper limit of normal [ULN]) and often resolve even without dose modification. The aminotransferase elevations are not accompanied by symptoms or increases in serum alkaline phosphatase or bilirubin levels and rarely require dose modification. There have been no reports of clinically apparent liver injury attributed to nitisinone in the treatment of tyrosinemia or in experimental studies of its use in other disorders of tyrosine metabolism such as alkaptonuria.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which nitisinone causes serum aminotransferase elevations is unclear. Increased intrahepatic levels of tyrosine or 4-hydroxyphenylacetate may have mild toxic effects on hepatocytes or other tissues leading to mild and transient aminotransferase release.

Drug Class: Genetic Disorder Agents (Liver Diseases), Enzyme Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nitisinone – Orfadin®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nitisinone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nitisinone | 104206-65-7 | C14-H10-F3-N-O5 | Nitisinone structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 October 2016

Zimmerman HJ. Bile acid derivatives. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 before the availability of nitisinone).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Lindstedt S, Holme E, Lock EA, Hjalmarson O, Strandvik B. Treatment of hereditary tyrosinaemia type I by inhibition of 4-hydroxyphenylpyruvate dioxygenase. Lancet 1992; 340 (8823): 813-7. (Initial report on use of nitisinone in humans; 5 children with type 1 tyrosinemia received nitisinone in doses of 0.1-0.6 mg/kg daily which led to clinical improvements in all including resolution of liver and renal abnormalities; “no side effects were encountered”). 1383656
New treatment for tyrosinaemia. Lancet 1992; 340 (8823): 822-3. (Editorial in response to report by Lindstedt [1992] discusses the biologic basis for inhibition of tyrosine metabolism and the likelihood that nitisinone could greatly improve quality of life and life expectancy in type 1 tyrosinemia “if these results are confirmed”). 1357248
Grompe M, Lindstedt S, al-Dhalimy M, Kennaway NG, Papaconstantinou J, Torres-Ramos CA, Ou CN, Finegold M. Pharmacological correction of neonatal lethal hepatic dysfunction in a murine model of hereditary tyrosinaemia type I. Nat Genet 1995; 10 (4): 453-60. (Description of an animal model of type 1 tyrosinemia, mice homozygous for fumarylacetoacetate hydrolase [FAH] deletion, and the effects of early therapy with nitisinone in reversing and preventing hepatic abnormalities including liver cancer). 7545495
Pronicka E, Rowinska E, Bentkowski Z, Zawadzki J, Holme E, Lindstedt S. Treatment of two children with hereditary tyrosinaemia type I and long-standing renal disease with a 4-hydroxyphenylpyruvate dioxygenase inhibitor (NTBC). J Inherit Metab Dis 1996; 19: 234-8. (Two children with type 1 tyrosinemia and a chronic course marked mainly by renal rickets were treated with nitisinone and both had remission in renal disease with reversal of phosphate wasting, aminoaciduria and glycosuria). 8739974
Lock EA, Ellis MK, Gaskin P, Robinson M, Auton TR, Provan WM, Smith LL, et al. From toxicological problem to therapeutic use: the discovery of the mode of action of 2-(2-nitro-4-trifluoromethylbenzoyl)-1,3-cyclohexanedione (NTBC), its toxicology and development as a drug. J Inherit Metab Dis 1998; 21: 498-506. (History of development of nitisinone [NTBC], initially as an herbicide, but after demonstration of inhibition of tyrosine metabolism in animals, as a potential therapy of type 1 tyrosinemia [Lindstedt 1992]). 9728330
Ros J, Vilaseca MA, Lambruschini N, Mas A, Lindstedt S, Holme E. NTBC as palliative treatment in chronic tyrosinaemia type I. J Inherit Metab Dis 1999; 22: 665-6. (A 17 year old boy with a long term history of liver disease, renal tubular dysfunction and severe osteomalaica was diagnosed with type 1 tyrosinemia and, despite the advanced nature of the disease, had a clinical response to dietary restriction and nitisinone, but died two years later with suspected liver cancer and respiratory failure). 10399099
Crone J, Möslinger D, Bodamer OA, Schima W, Huber WD, Holme E, Stöckler Ipsiroglu S. Reversibility of cirrhotic regenerative liver nodules upon NTBC treatment in a child with tyrosinaemia type I. Acta Paediatr 2003; 92 (5): 625-8. (4 week old boy with acute tyrosinemia, type 1, was treated with nitisinone and low tyrosine diet and had reversal of liver failure and subsequent normal growth and development). 12839296
Joshi SN, Venugopalan P. Experience with NTBC therapy in hereditary tyrosinaemia type I: an alternative to liver transplantation. Ann Trop Paediatr 2004; 24: 259-65. (5 infants with acute onset type 1 tyrosinemia started nitisinone therapy after 6-30 months of life and showed remarkable improvement within 2-6 months; therapy was “well tolerated without side-effects”). 15479577
Suwannarat P, O'Brien K, Perry MB, Sebring N, Bernardini I, Kaiser-Kupfer MI, Rubin BI, et al. Use of nitisinone in patients with alkaptonuria. Metabolism 2005; 54: 719-28. (In a pilot study of nitisinone in 9 adults with alkaptonuria, all had a prompt and marked decrease in urinary homogentisic acid levels and most had improvements in arthritic pain, while side effects included ten-fold increases in tyrosine levels and mild increases in ALT levels [without increases in Alk P or bilirubin] in 5 patients [peak ALT 144 U/L], but abnormalities were asymptomatic and resolved within 1-3 weeks in 2 who stopped therapy). 15931605
Masurel-Paulet A, Poggi-Bach J, Rolland MO, Bernard O, Guffon N, Dobbelaere D, Sarles J, et al. NTBC treatment in tyrosinaemia type I: long-term outcome in French patients. J Inherit Metab Dis 2008; 31: 81-7. (Among 46 French patients with type 1 tyrosinemia treated with a low protein diet and nitisinone for 3 months to 12 years [mean=4 years: dose 0.5-1.7 mg/kg daily], 4 required liver transplantation and two developed liver cancer, but most had a long term beneficial outcome; liver enzyme elevations during therapy were rare, almost all less than twice ULN and all were asymptomatic and resolved spontaneously). 18214711
McKiernan PJ. Nitisinone in the treatment of hereditary tyrosinaemia type 1. Drugs 2006; 66 (6): 743-50. (Review of efficacy and safety of nitisinone in type 1 tyrosinemia, which results in resolution of liver failure in up to 90% of patients and improves renal tubular dysfunction as well, while adverse events are not common but can include marked elevations in serum tyrosine levels with possible corneal irritation and ulceration; no mention of liver injury). 16706549
El-Karaksy H, Fahmy M, El-Raziky M, El-Koofy N, El-Sayed R, Rashed MS, El-Kiki H, El-Hennawy A, Mohsen N. Hereditary tyrosinemia type 1 from a single center in Egypt: clinical study of 22 cases. World J Pediatr 2011; 7: 224-31. (Among 4 Egyptian patients with type 1 tyrosinemia treated with nitisinone for 1-2 years, all had a clinical response and most were treated with less than 1 mg/kg daily, suggesting that lower doses may be as effective as the recommended doses of 1-2 mg/kg daily). 21633861
Introne WJ, Perry MB, Troendle J, Tsilou E, Kayser MA, Suwannarat P, O'Brien KE, et al. A 3-year randomized therapeutic trial of nitisinone in alkaptonuria. Mol Genet Metab 2011; 103: 307-14. (Among 40 patients with alkaptonuria treated with nitisinone [2 mg daily] or no therapy for 3-4 years, homogentisic acid levels decreased into the normal range in all treated subjects, but arthritic symptoms or signs did not improve more with nitisinone compared to placebo therapy and adverse events included corneal opacities in one and fluctuating ALT elevations in another patient, with a peak level of 225 U/L which resolved upon stopping).
Couce ML, Dalmau J, del Toro M, Pintos-Morell G, Aldámiz-Echevarría L; Spanish Working Group on Tyrosinemia type 1. Tyrosinemia type 1 in Spain: mutational analysis, treatment and long-term outcome. Pediatr Int 2011; 53: 985-9. (Among 34 Spanish patients with type 1 tyrosinemia treated with nitisinone [mean dose 0.9 mg/kg daily], only 1 patient required liver transplantation and none developed liver cancer). 21752152
Wisse RP, Wittebol-Post D, Visser G, van der Lelij A. Corneal depositions in tyrosinaemia type I during treatment with nitisinone. BMJ Case Rep 2012; 2012. (A 17 year old boy with type 1 tyrosinemia treated with nitisinone [70 mg daily; duration not provided] developed corneal irritation and deposits which were suspected to be due to high plasma tyrosine levels, but actual values and outcome were not provided). 23203167
Larochelle J, Alvarez F, Bussières JF, Chevalier I, Dallaire L, Dubois J, Faucher F, et al. Effect of nitisinone (NTBC) treatment on the clinical course of hepatorenal tyrosinemia in Québec. Mol Genet Metab 2012; 107: 49-54. (Retrospective analysis of 78 patients from Quebec with type 1 tyrosinemia seen between 1984 and 2004 found that 20 of 28 [71%] who never received nitisinone ultimately required liver transplantation compared to 7 of 26 [28%] who were treated late and none of 24 who started therapy early [before 30 days of age]; ALT elevations [above 60 U/L] occurred in 12 of 50 treated subjects [24%], but all were mild and transient [peak values 60-580 U/L] and did not require dose modification; no patient treated early developed liver disease or acute neurologic crisis). 22885033
Schlune A, Thimm E, Herebian D, Spiekerkoetter U. Single dose NTBC-treatment of hereditary tyrosinemia type I. J Inherit Metab Dis 2012; 35: 831-6. (Plasma nitisinone levels did not change in 7 patients with tyrosinemia who were switched from twice to once daily dosing and turnover studies suggested a 54 hour half-life, indicating that once daily dosing might be optimal for routine, maintenance use). 22307209
Thimm E, Richter-Werkle R, Kamp G, Molke B, Herebian D, Klee D, Mayatepek E, et al. Neurocognitive outcome in patients with hypertyrosinemia type I after long-term treatment with NTBC. J Inherit Metab Dis 2012; 35: 263-8. (Among 9 children with type 1 tyrosinemia treated since infancy with nitisinone, cognitive, neuromuscular and language development were below average in most and plasma tyrosine levels were high in all [12 month medians 403-804 µmol/L], suggesting that abnormal intellectual development is a feature of tyrosinemia and may be exacerbated by nitisinone therapy and the resultant, chronic elevation in tyrosine plasma levels). 22069142
Vanclooster A, Devlieger R, Meersseman W, Spraul A, Kerckhove KV, Vermeersch P, Meulemans A, et al. Pregnancy during nitisinone treatment for tyrosinaemia type I: first human experience. JIMD Rep 2012; 5: 27-33. (A 19 year old woman with tyrosinemia had a normal pregnancy and newborn despite continuation of nitisinone therapy during pregnancy [0.5 mg/kg daily]). 23430914
Bartlett DC, Lloyd C, McKiernan PJ, Newsome PN. Early nitisinone treatment reduces the need for liver transplantation in children with tyrosinaemia type 1 and improves post-transplant renal function. J Inherit Metab Dis 2014; 37: 745-52. (Retrospective analysis of 38 patients with tyrosinemia followed between 1989 and 2009 at a UK referral center found the rate of liver transplantation fell from 86% before 1992 compared to 23% thereafter, and children starting nitisinone early were least likely to ultimately require transplantation). 24515874
Bendadi F, de Koning TJ, Visser G, Prinsen HC, de Sain MG, Verhoeven-Duif N, Sinnema G, et al. Impaired cognitive functioning in patients with tyrosinemia type I receiving nitisinone. J Pediatr 2014; 164: 398-401. (Cross sectional study of 10 patients with type 1 tyrosinemia and their healthy siblings found lower IQs in patients vs controls [mean=71 vs 91] and serial testing in 5 patients found declines in IQ during nitisinone therapy, the impaired cognitive function being attributed to high plasma tyrosine levels [above 1500 µmol/L, normal 40-90 µmol/L]). 24238861
Mayorandan S, Meyer U, Gokcay G, Segarra NG, de Baulny HO, van Spronsen F, Zeman J, et al. Cross-sectional study of 168 patients with hepatorenal tyrosinaemia and implications for clinical practice. Orphanet J Rare Dis. 2014; 9: 107. (Among 168 patients with type 1 tyrosinemia from 21 centers in Europe, Turkey and Israel, the average age at diagnosis was 12.9 months; 154 received nitisinone for an average of 7.6 years, dose averaged 1.7 mg/kg daily, usually in 2 divided doses daily, 29 [17%] had liver transplantation [72% for liver cancer]; side effects included eye pain or itching [6%], corneal crystals [3%], thrombocytopenia [5%], and leukopenia [2%]; no mention of ALT elevations or hepatotoxicity). 25081276
Kassel R, Sprietsma L, Rudnick DA. Pregnancy in an NTBC-treated patient with hereditary tyrosinemia type I. J Pediatr Gastroenterol Nutr 2015; 60: e5-7. (A 16 year old girl with tyrosinemia on long term nitisinone therapy became pregnant and delivered a normal, full term infant despite continuing treatment during entire pregnancy; tyrosine levels were elevated in the newborn, but rapidly fell into the normal range). 23838819
Gertsman I, Barshop BA, Panyard-Davis J, Gangoiti JA, Nyhan WL. Metabolic effects of increasing doses of nitisinone in the treatment of alkaptonuria. JIMD Rep 2015; 24: 13-20. (Among 7 patients with alkaptonuria treated with escalating doses of nitisinone, urinary homogentisic acid levels decreased with increasing doses from 2-4 mg daily while serum tyrosine levels remained constant, suggesting that previous studies in alkaptonuria had used suboptimal doses [Introne 2011]). 25665838
Zeybek AC, Kiykim E, Soyucen E, Cansever S, Altay S, Zubarioglu T, Erkan T, et al. Hereditary tyrosinemia type 1 in Turkey: twenty year single-center experience. Pediatr Int 2015; 57: 281-9. (Among 38 Turkish patients with type 1 tyrosinemia seen at a single referral center over a 20 year period, 36 were treated with nitisinone of whom 6 ultimately underwent liver transplantation, 4 for suspected liver cancer and 2 for noncompliance, and “no adverse effect required interruption of nitisinone treatment”, but no mention of ALT elevations). 25223216
Simoncelli M, Samson J, Bussières JF, Lacroix J, Dorais M, Battista R, Perreault S. Cost-consequence analysis of nitisinone for treatment of tyrosinemia type I. Can J Hosp Pharm 2015; 68: 210-7. (Economic analysis concludes that nitisinone therapy decreases health care costs and is cost effective despite yearly price of more than $50,000). 26157182
Ranganath LR, Milan AM, Hughes AT, Dutton JJ, Fitzgerald R, Briggs MC, Bygott H, et al. Suitability Of Nitisinone In Alkaptonuria 1 (SONIA 1): an international, multicentre, randomised, open-label, no-treatment controlled, parallel-group, dose-response study to investigate the effect of once daily nitisinone on 24-h urinary homogentisic acid excretion in patients with alkaptonuria after 4 weeks of treatment. Ann Rheum Dis 2016; 75: 362-7. (Among 40 patients with alkaptonuria treated with nitisinone [1, 2, 4 or 8 mg daily] or placebo for 4 weeks, urinary homogentisic acid levels fell in a dose related manner, the most efficacious dose being 8 mg daily [99% decrease] while plasma tyrosine levels were elevated at all doses, ranging from 400-1117 µmol/L and there were “no changes in clinical chemistry” results). 25475116
Das AM. Pharmacotherapy of inborn errors of metabolism illustrating challenges in orphan diseases. J Pharmacol Toxicol Methods 2016; 81: 9-14. (Review of pharmacologic approaches to therapy of inborn errors of metabolism using substrate reduction, vitamins and cofactors, enzyme replacement or augmentation and transplantation, includes discussion of phenylketonuria, tyrosinemia, Gaucher disease and the urea cycle disorders). 26921514
Gokay S, Ustkoyuncu PS, Kardas F, Kendirci M. The outcome of seven patients with hereditary tyrosinemia type 1. J Pediatr Endocrinol Metab. 2016 Sep 28. [Epub ahead of print] (Among 7 Turkish children with type 1 tyrosinemia who were treated with nitisinone, all had a clinical response, but one noncompliant child developed hepatocellular carcinoma at 10 years of age; no adverse events required discontinuation, but 2 children developed corneal opacities that resolved with strict adherence to low protein diet). 27682708
In brief: Nitisinone (Orfadin) for hereditary tyrosinemia. Med Lett Drugs Ther 2016; 58 (1505): e132. (Short review of the efficacy, safety and costs of a new oral suspension formulation of nitisinone). 27701365

## OTHER REFERENCE LINKS

1. Recent References on Nitisinone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nitisinone)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nitisinone) Trials on Nitisinone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nitisinone)